# Tebentafusp

## OVERVIEW

### Introduction

Tebentafusp is a recombinant bispecific fusion protein that binds both the gp100 peptide expressed in HLA-A*02:01 on melanoma cells and the CD3 T cell engager. It is used to treat metastatic or unresectable uveal melanoma. Tebentafusp is associated with frequent elevations in serum ALT, AST and bilirubin during therapy, usually in association with cytokine release syndrome that can lead to interruption or early discontinuation of therapy, but instances of clinically apparent liver injury with jaundice independent of cytokine release syndrome have not been reported.

### Background

Tebentafusp (te ben’ ta fusp) is a recombinant bispecific fusion protein that binds both the gp100 peptide expressed in HLA-A*02:01 on melanoma cells and the CD3 T cell engager. HLA-A*02:01 is the most common HLA complex in humans found in 50% of persons with European American ancestry. Thus, tebentafusp activates cytotoxic CD3 T cells in the presence of melanoma expressed gp100 peptide causing an immune lysis of the melanoma cells. Tebentafusp was found to be effective in animal models of human uveal melanoma, a particularly resistant and rapidly fatal form of the malignancy. In a randomized controlled trial in patients with metastatic uveal melanoma, tebentafusp was associated with an improvement in one year survival compared to standard melanoma therapies (73% vs 59%). Tebentafusp was approved in the United States in 2022 as therapy of metastatic or unresectable uveal melanoma in adults with HLA-A*02:01. It remains under evaluation in other forms of advanced melanoma. Tebentafusp is available in solution for injection in single dose vials of 100 mcg in 0.5 mL (200 mcg/mL) under the brand name Kimmtrak. The recommended dose is once weekly intravenous infusions of 20 mcg on day 1, 30 mcg on day 8, and 68 mcg on day 15 and once weekly thereafter. Tebentafusp has a high rate of adverse events, most commonly a mild-to-moderate cytokine release syndrome caused by the generalized activation of CD3 T cells. Symptoms include fever, chills, fatigue, rash, pruritus, dry skin, abdominal pain, nausea, vomiting, headache, hypotension, edema, dyspnea. Laboratory abnormalities include lymphopenia and anemia, as well as increase in glucose, creatinine, serum ALT, AST and bilirubin levels. Potentially severe adverse events include severe cytokine release syndrome and embryo-fetal toxicity.

### Hepatotoxicity

In prelicensure controlled trials, serum ALT or AST elevations occurred in 65% of tebentafusp treated subjects arising in association with cytokine release syndrome that typically occurs during the first few months of therapy. Most of these elevations were mild-to-moderate in severity and resolved rapidly despite continuation of treatment. ALT elevations arose in 52% of tebentafusp treated patients and were above 5 times the ULN in 9%, compared to the comparator arm receiving standard therapy for melanoma in whom ALT elevations arose in 29% and were above 5 times ULN in 2%. Bilirubin elevations were also more frequent (27% vs 14% in comparator arms). ALT or AST elevations led to temporary interruption of therapy in 5% of patients but to permanent discontinuation in only 0.4%. Most liver enzyme and bilirubin elevations occurred in the context of cytokine release syndrome. In preregistration clinical trials and subsequently with its more widespread use, tebentafusp has not been linked to instances of clinically apparent liver injury independent of the cytokine release syndrome.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

Tebentafusp is a recombinant human protein and as such is unlikely to be intrinsically hepatotoxic. Because tebentafusp induces a strong CD3 T cell response to the tumor antigen, it causes release of proinflammatory cytokines that can induce transient liver injury, the recombinant fusion protein being a cause of transient “indirect” drug induced liver injury. Because melanoma is also frequently found in liver, the lysis of liver melanoma cells and local release of inflammatory cytokines may particularly induce evidence liver injury and dysfunction.

### Outcome and Management

Tebentafusp has been linked to mild-to-moderate serum enzyme elevations during therapy. Discontinuation for serum enzyme elevations is usually not necessary, but should be done if the elevations are persistently above 5 times ULN. There is no information on cross sensitivity to liver injury between tebentafusp and other growth factors or therapies for melanoma.

Drug Class: Antineoplastic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES; Tebentafusp – Kimmtrak®; DRUG CLASS; Antineoplastic Agents; COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tebentafusp); Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Tebentafusp | 1874157-95-5 | Recombinant Protein | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 30 July 2023

Abbreviations used: CRS, cytokine release syndrome; iv, intravenous; TCR, T cell receptor.

FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2022/761228Orig1s000MultidisciplineR.pdf (FDA website including product label and multidiscipline review of data submitted in support of the approval of tebentafusp, mentions that ALT and AST elevations arose in two-thirds of treated patients, and qualified as being serious adverse events in 11 [4.4%], resulting in withholding therapy in 13 [15%] and permanent discontinuation in one patient [0.4%], but there were no liver related deaths).
Middleton MR, McAlpine C, Woodcock VK, Corrie P, Infante JR, Steven NM, Evans TRJ, et al. Tebentafusp, a TCR/Anti-CD3 bispecific fusion protein targeting gp100, potently activated antitumor immune responses in patients with metastatic melanoma. Clin Cancer Res. 2020;26:5869-5878. (Among 84 patients with advanced metastatic melanoma [19 with uveal melanoma] who were treated with various dose regimens of tebentafusp intravenously [iv], the one year survival rate was 60% while the overall response rate was only 9%, and 60% of patients had the cytokine release syndrome [CRS] with levels of cytokines highest for CXCL11, CXCL10, IL2, IL6 and IL10, and best survival achieved in patients with the highest CXCL10 levels and appearance of rash within 21 days). 32816891
Nathan P, Hassel JC, Rutkowski P, Baurain JF, Butler MO, Schlaak M, Sullivan RJ, et al.; IMCgp100-202 investigators. Overall survival benefit with tebentafusp in metastatic uveal melanoma. N Engl J Med. 2021;385:1196-1206. (Among 378 treatment-naive, HLA-A*02:01-positive patients with metastatic uveal melanoma treated with weekly iv tebentafusp or with preferred standard therapies, overall 1-year survival rates were 73% vs 59% and the most frequent tebentafusp related adverse event was CRS [89% vs 3%], and ALT elevations arose in 18% vs 7% and bilirubin in 9% vs 2%, usually during the first 4 weeks of therapy). 34551229
Carvajal RD, Nathan P, Sacco JJ, Orloff M, Hernandez-Aya LF, Yang J, Luke JJ, et al. Phase I study of safety, tolerability, and efficacy of tebentafusp using a step-up dosing regimen and expansion in patients with metastatic uveal melanoma. J Clin Oncol. 2022;40:1939-1948. (Among 42 adults with refractory metastatic uveal melanoma and HLA-A*02:01 treated with escalating doses of tebentafusp [20, 30, 54 and 68 mcg], the 68 mcg dose was chosen for future study, and the overall response rate was 12%, 1-year survival rate 67%, and most frequent adverse events were fever [91%], rash [83%], pruritus [83%], nausea [74%] and fatigue [71%]; while ALT elevations arose in 5%, AST in 7%, and bilirubin in 5%, there were no discontinuations for liver test abnormalities and no treatment-related deaths). 35254876
Dhillon S. Tebentafusp: first approval. Drugs. 2022;82:703-710. (Review of the mechanism of action, history of development, pharmacokinetics, clinical efficacy, and safety shortly after its approval as therapy of uveal melanoma in the US, mentions that CRS developed in 89% of patients [defined as presence of fever, hypotension and hypoxia] but was usually mild-to-moderate in severity with grade 3 CRS in only 1% of subjects and no cases of death from CRS, and while ALT and AST elevations were frequent [65-71%], they were usually mild-to-moderate and, if more severe [in 4-16%], were often self-limited even with continuing therapy). 35364798
Carvajal RD, Butler MO, Shoushtari AN, Hassel JC, Ikeguchi A, Hernandez-Aya L, Nathan P, et al. Clinical and molecular response to tebentafusp in previously treated patients with metastatic uveal melanoma: a phase 2 trial. Nat Med. 2022;28:2364-2373. (Among 127 patients with refractory, metastatic uveal melanoma and HLA A*02:01 treated with tebentafusp, the primary response rate was only 5% but the one year median survival rate was 62%, higher than the established historical rate of only 37% ). 36229663

## OTHER REFERENCE LINKS

Recent References on Tebentafusp: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tebentafusp+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Tebentafusp: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tebentafusp)